# Fosnetupitant

## OVERVIEW

### Introduction

Fosnetupitant is an antiemetic agent that is given in combination with palonosetron and dexamethasone to prevent nausea and vomiting from cancer chemotherapy. When given in combination, fosnetupitant and palonosetron have not been associated with liver related serum enzyme elevations during therapy or to cases of clinically apparent liver injury with jaundice.

### Background

Fosnetupitant (fos” ne tu’ pi tant) is a prodrug of netupitant, a substance P antagonist that blocks the neurokinin 1 (NK1) receptor, which is found in the central nervous system and induces the vomiting reflex when activated by its ligand, substance P. Fosnetupitant has been shown to inhibit both acute and delayed nausea and vomiting associated with cancer chemotherapy. It appears to act synergistically with serotonin type 3 (5-HT3) receptor blockers such as palonosetron which predominantly inhibits early nausea and vomiting after cancer chemotherapy. Fosnetupitant in fixed combination with palonosetron was shown to reduce both early and late nausea and vomiting from highly emetogenic cancer chemotherapy regimens. The fixed combination was approved for use in the United States in both oral and parenteral forms in 2018. Current indications are for prevention of chemotherapy associated nausea and vomiting only and concurrent therapy with dexamethasone is recommended for highly emetogenic regimens. The fixed combination is available as capsules of 300 mg of netupitant and 0.5 mg of palonosetron for oral use, and as lyophilized powder for reconstitution in single use vials of 235 mg of fosnetupitant and 0.25 mg of palonosetron for parenteral use, under the brand name Akynzeo. The recommended dose regimen calls for one capsule of the oral combination to be given one hour before chemotherapy and the full vial of reconstituted intravenous combination starting 30 minutes before chemotherapy. Oral dexamethasone is given orally on days 1 (12 mg) and days 2 to 4 (8 mg) in those receiving highly emetogenic regimens of chemotherapy, but is not recommended for less emetogenic regimens. Common side effects of both oral and intravenous fosnetupitant and palonosetron include fatigue, drowsiness, dizziness, headache, diarrhea and abdominal discomfort. Rare but potentially severe adverse events include hypersensitivity reactions including anaphylaxis and serotonin syndrome, particularly when given with other serotonergic drugs. Fosnetupitant with palonosetron should be administered only by health care providers with training and experience in managing cancer chemotherapy and its side effects.

### Hepatotoxicity

In preregistration clinical trials of the fixed combination of fosnetupitant and palonosetron, serum aminotransferase elevations occurred in a similar proportion of treated patients as controls receiving cancer chemotherapy. The aminotransferase elevations were transient, mild-to-moderate in severity, and not associated with symptoms or jaundice. The elevations were more likely due to the cancer chemotherapy than the antiemetic prophylaxis. There have been no convincing cases of clinically apparent liver injury attributable to fosnetupitant with palonosetron published in the literature and thus, significant liver injury must be exceedingly rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Fosnetupitant is metabolized by and inhibits hepatic CYP 3A4 and has the potential to cause significant drug-drug interactions. It also has significant interactions with warfarin and with hormonal contraceptives. The lack of reported cases of liver injury due to fosnetupitant with palonosetron may be due to the low doses and short duration of typical therapy.

Drug Class: Gastrointestinal Agents, Antiemetic Agents

Other Drugs in the Subclass, Substance P/Neurokinin-1 Receptor Antagonists: Aprepitant, Fosaprepitant, Rolapitant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fosnetupitant – Akynzeo®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fosnetupitant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fosnetupitant | 1703748-89-3 | C31-H35-F6-N4-O5-P

## ANNOTATED BIBLIOGRAPHY

References updated: 28 February 2024

Abbreviations used: 5-HT3, 5-hydroxytryptamine type 3 [serotonin]; iv, intravenous; NEPA, fixed combination of netupitant [or fosnetupitant] and palonosetron; NK-1, neurokinin-1.

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 before the availability of aprepitant, netupitant, and fosnetupitant).
Sharkey KA, McNaughton WK. Gastrointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. 2010;52:2065–2076. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to an antiemetic agent). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. 2013;144:1419–1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antiemetics). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata RA, Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. 2014;13:231–239. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13], and flutamide [n=12: 7%]; no antiemetic was listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. 2015;148:1340–52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to aprepitant or other antiemetic agents). 25754159
IV aprepitant (Cinvanti) for chemotherapy-induced nausea and vomiting. Med Lett Drugs Ther. 2018;60(1561):e200–e201. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of aprepitant, the first substance P inhibitor approved for prevention of nausea and vomiting after highly emetogenic chemotherapy, in discussing adverse events does not mention ALT elevations or hepatotoxicity). 30653479
Schwartzberg L, Roeland E, Andric Z, Kowalski D, Radic J, Voisin D, Rizzi G, et al. Phase III safety study of intravenous NEPA: a novel fixed antiemetic combination of fosnetupitant and palonosetron in patients receiving highly emetogenic chemotherapy. Ann Oncol. 2018;29:1535–1540. (Among 404 patients who received fixed doses of netupitant and palonosetron as oral capsules [300 mg, 0.50 mg] vs intravenous [iv] formulations [235 mg/0.25 mg] before 1312 cycles of highly emetogenic chemotherapy regimens, treatment related adverse event rates were similar in the two groups [9.5% vs 8.9%], although ALT elevations were more frequent after oral administration [any elevations 11.9% vs 7.4%; elevations above 5 times ULN 7% vs 1%]). 29722791
Sugawara S, Inui N, Kanehara M, Morise M, Yoshimori K, Kumagai T, Fukui T, et al. Multicenter, placebo-controlled, double-blind, randomized study of fosnetupitant in combination with palonosetron for the prevention of chemotherapy-induced nausea and vomiting in patients receiving highly emetogenic chemotherapy. Cancer. 2019;125:4076–4083. (Among 594 Japanese patients treated with fosnetupitant [81 or 235 mg] or placebo combined with palonosetron [0.75 mg] intravenously before highly emetogenic chemotherapy with dexamethasone for 4 days, prevention of nausea and vomiting was 55% for placebo, vs 64% and 77% with fosnetupitant while adverse event rates were similar including ALT elevations in 4.1% vs 5.6% and 5.6%). 31381152
Karthaus M, Voisin D, Rizzi G, Ciuleanu T. Phase 3 study of palonosetron IV infusion vs. iv bolus for chemotherapy-induced nausea and vomiting prophylaxis after highly emetogenic chemotherapy. J Pain Symptom Manage. 2020;60:568–576. (Among 440 patients who received a single iv infusion or iv bolus of palonosetron [0.25 mg] immediately before highly emetogenic chemotherapy, a similar proportion of each group had no emesis in the next 5 days [76% vs 77%], with similar rates of adverse events [38% vs 36%]; no mention of ALT levels or hepatotoxicity). 32276098
Schwartzberg L, Navari R, Clark-Snow R, Arkania E, Radyukova I, Patel K, Voisin D, et al. Phase IIIb safety and efficacy of intravenous NEPA for prevention of chemotherapy-induced nausea and vomiting (CINV) in patients with breast cancer receiving initial and repeat cycles of anthracycline and cyclophosphamide (AC) chemotherapy. Oncologist. 2020;25:e589–e597. (Among 402 patients treated with either oral or intravenous fosnetupitant and palonosetron [NEPA] just before a moderately or highly emetogenic cancer chemotherapy regimen, rates of no emesis over the next 5 days were similar in the two groups [oral 77% vs iv 73%], while treatment related adverse event rates were low and similar [11% vs 8%], there being only one treatment related serious adverse event, and no episodes of hypersensitivity or anaphylaxis; no mention of ALT elevations or hepatotoxicity). 32162813
Aapro M, Navari RM, Roeland E, Zhang L, Schwartzberg L. Efficacy of intravenous NEPA, a fixed NK/5-HT receptor antagonist combination, for the prevention of chemotherapy-induced nausea and vomiting (CINV) during cisplatin- and anthracycline cyclophosphamide (AC)-based chemotherapy: a review of phase 3 studies. Crit Rev Oncol Hematol. 2021;157:103143. (Analysis of 15 studies of NK-1 receptor inhibitors compared to 5-HT3 receptor inhibitors, including 2077 patients treated with both netupitant and palonosetron [NEPA], 403 orally and 1674 intravenously [iv], the overall complete response with cisplatin regimens was 77% for iv NEPA, which was similar for oral [75-90%], and was higher than that with other NK-1/5-HT3 combinations [66-78%], mentions that NK-1 inhibitors were “safe and well tolerated”; no discussion of ALT elevations or hepatotoxicity). 33260048
Hata A, Okamoto I, Inui N, Okada M, Morise M, Akiyoshi K, Takeda M, et al. Randomized, double-blind, phase III study of fosnetupitant versus fosaprepitant for prevention of highly emetogenic chemotherapy-induced nausea and vomiting: CONSOLE. J Clin Oncol. 2022;40:180–188. (Among 795 patients treated with iv fosnetupitant or fosaprepitant combined with iv palonosetron and 4 days of oral dexamethasone, the complete response rates were 75% vs 71% and treatment related adverse event rates 22% vs 25%, while injection site reactions were less with NEPA [11% vs 21%]). 34793245
Matsuura K, Tsurutani J, Inoue K, Tanabe Y, Taira T, Kubota K, Tamura T, et al. A phase 3 safety study of fosnetupitant as an antiemetic in patients receiving anthracycline and cyclophosphamide: CONSOLE-BC. Cancer. 2022;128:1692–1698. (Among 102 patients treated with iv fosnetupitant or fosaprepitant in combination with palonosetron before receiving cancer chemotherapy, the complete response rate was 46% vs 51% and treatment related adverse event rates were similar [21% vs 22%], although injection site reactions were less frequent with fosnetupitant [6% vs 26%). 35045185
Dranitsaris G, Moezi M, Dobson K, Phelan R, Blau S. A real-world study to evaluate the safety and efficacy of three injectable neurokinin-1 receptor antagonist formulations for the prevention of chemotherapy-induced nausea and vomiting in cancer patients. Support Care Cancer. 2022;30:6649–6658. (Among 294 adults receiving prophylaxis for nausea and vomiting for cancer chemotherapy in 17 community hospitals, those receiving fosaprepitant had slightly lower rates of control of nausea and vomiting and higher rates of infusion reactions compared to those receiving fosnetupitant, while most other adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 35499619

## OTHER REFERENCE LINKS

Recent References on Fosnetupitant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fosnetupitant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Fosnetupitant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fosnetupitant)